# Nateglinide

## OVERVIEW

### Introduction

Nateglinide is an oral hypoglycemic agent and amino acid derivative that stimulates insulin secretion from the pancreas and is used in the therapy of type 2 diabetes. Nateglinide has been linked to rare instances of clinically apparent acute liver injury.

### Background

Nateglinide (na teg' li nide) is an insulin secretagogue that is similar in action but different in structure from the sulfonylureas. It is a derivative of phenylalanine and stimulates insulin secretion by blocking ATP sensitive potassium channels in pancreatic beta-cells, causing cell membrane depolarization which results in calcium influx and insulin secretion. Nateglinide has been shown to reduce the postprandial increase in glucose in patients with type 2 diabetes and improve glycemic control. Nateglinide was approved for use in the United States in 2000. The current indications are for management of type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents. Nateglinide is available generically and under the brand name Starlix in tablets of 60 and 120 mg. The typical initial dose in adults is 120 mg three times daily before meals. Side effects of nateglinide include diarrhea, nausea, gastrointestinal upset, hypoglycemia, dizziness and rash.

### Hepatotoxicity

In several large clinical trials, serum aminotransferase elevations were no more common with nateglinide than with placebo. The enzyme elevations that occurred were asymptomatic and resolved rapidly with stopping therapy. Since its approval and with wide scale use, the FDA and the sponsor have received reports of clinically apparent liver injury attributed to nateglinide. However, none of these cases has been published and the clinical features, time to onset, course and outcome of the injury have not been described. The metiglinide analogue repaglinide has been impicated in rare cases of cholestatic or mixed hepatitis, but whether nateglinide liver injury is similar is not known. Thus, nateglinide is likely to be a very rare cause of clinically apparent liver disease.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of nateglinide induced liver injury is not known, but nateglinide is extensively metabolized by the liver via the P450 system (CYP 2C9 and 3A4), and liver injury may be the result of production of a toxic or immunoreactive intermediate.

### Outcome and Management

There is no information on results of rechallenge on cross sensitivity to hepatic damage among the various metiglinides. Reexposure and use of other metiglinides after clinically apparent liver injury related to nateglinide should be done with caution.

References regarding the safety and hepatotoxicity of nateglinide and repaglinide are given with the Overview section on the Metiglinide Analogues (updated June 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass Metiglinide Analogues: Repaglinide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nateglinide – Generic, Starlix®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nateglinide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nateglinide | 105816-04-4 | C19-H27-N-O3 | Nateglinide Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Nateglinide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nateglinide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nateglinide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nateglinide)